# Pramlintide

## OVERVIEW

### Introduction

Pramlintide is a recombinant DNA produced polypeptide analogue of human amylin that is used in combination with insulin in the therapy of diabetes. Pramlintide has not been associated with serum enzyme elevations during therapy or with instances of clinically apparent liver injury.

### Background

Pramlintide (pram' lin tide) is a synthetic analogue of human amylin that is used in combination with insulin in the treatment of diabetes. Amylin is a human pancreatic hormone which, like insulin, is produced in pancreatic beta cells and aids in the control of blood sugar after meals by delaying gastric emptying, decreasing glucagon secretion and suppressing appetite. The loss of beta cell function that occurs early in type 1 diabetes and late in type 2 diabetes leads to deficiency in amylin secretion. Pramlintide differs from human amylin in 3 of its 37 amino acids, modifications which allow for a longer half-life of the hormone. Pramlintide was approved for use in diabetes as an adjunct to insulin therapy in the United States in 2005. Pramlintide is available in solution in vials and pens for injection under the brand name Symlin. The typical starting dose in type 1 diabetes is 15 µg subcutaneously before each meal, with subsequent titration to a target dose of 60 µg before each meal. The recommended starting dose in type 2 diabetes is 60 µg, with a target maintenance dose of 120 µg subcutaneously before each meal. Common side effects of pramlintide include nausea, vomiting, anorexia, fatigue, headache, dizziness and hypoglycemia. Severe adverse reactions include severe hypoglycemia, particularly in type 1 diabetes.

### Hepatotoxicity

In large clinical trials, serum enzyme elevations were rare (<1%) during pramlintide/insulin therapy and no more common than with placebo and there were no reports of clinically apparent liver injury among treated patients. Since licensure, there have been no published case reports of hepatotoxicity due to pramlintide and the product label does not list liver injury as an adverse event. Thus, liver injury due to pramlintide must be rare, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Pramlintide is a polypeptide and is metabolized to amino acids by serum and tissue proteases, and is unlikely to have any direct hepatotoxic potential.

Drug Class: Antidiabetic Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Pramlintide – Symlin®

DRUG CLASS

Antidiabetic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Pramlintide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Pramlintide | 151126-32-8 | Protein | Complex Polypeptide

## ANNOTATED BIBLIOGRAPHY

References updated: 06 June 2016

Zimmerman HJ. Oral hypoglycemic agents and other diabetes therapy. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999: pp. 575-9. (Textbook of hepatotoxicity published in 1999, before the availability of pramlintide).
De Marzio DH, Navarro VJ. Antidiabetic drugs. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 528-32. (Review of hepatotoxicity of drugs for diabetes; mentions that there have been no reports of hepatotoxicity attributable to pramlintide).
Powers AC, D'Alessio D. Therapy of diabetes. Endocrine pancreas and pharmacotherapy of diabetes mellitus and hypoglycemia. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1248-67. (Textbook of pharmacology and therapeutics).
Thompson RG, Peterson J, Gottlieb A, Mullane J. Effects of pramlintide, an analog of human amylin, on plasma glucose profiles in patients with IDDM: results of a multicenter trial. Diabetes 1997; 46: 632-6. (Among 168 patients with diabetes on insulin therapy treated with 1 of 3 doses of pramlintide or placebo 4 times daily for a 2 week period, side effects included nausea, anorexia and dyspepsia; no mention of ALT elevations or hepatotoxicity). 9075803
Hollander PA, Levy P, Fineman MS, Maggs DG, Shen LZ, Strobel SA, Weyer C, et al. Pramlintide as an adjunct to insulin therapy improves long-term glycemic and weight control in patients with type 2 diabetes: a 1-year randomized controlled trial. Diabetes Care 2003; 26: 784-90. (Among 636 patients with diabetes on insulin who were treated with one of 3 doses of pramlintide or placebo for 52 weeks, there was greater decline in HbA1c and weight loss with pramlintide and there was “no evidence of … hepatic … toxicity or drug-related idiosyncratic side effects”). 12610038
Ratner RE, Dickey R, Fineman M, Maggs DG, Shen L, Strobel SA, Weyer C, et al. Amylin replacement with pramlintide as an adjunct to insulin therapy improves long-term glycaemic and weight control in Type 1 diabetes mellitus: a 1-year, randomized controlled trial. Diabet Med 2004; 21: 1204-12. (Among 651 patients with type 1 diabetes on insulin treated with mealtime injections of 3 doses of pramlintide or placebo for up to 52 weeks, therapy led to a decrease in HbA1c levels, and side effects were mainly nausea, vomiting and anoxia, with a 40% drop out rate). 15498087
Pramlintide(symlin) for diabetes. Med Lett Drugs Ther 2005; 47 (1209): 43-4. (Concise summary of mechanism of action, clinical efficacy, side effects and costs of pramlintide shortly after its approval for use in the US, mentions side effects of anorexia, nausea and vomiting, headache and hypoglycemia). 15912124
Edelman S, Garg S, Frias J, Maggs D, Wang Y, Zhang B, Strobel S, et al. A double-blind, placebo-controlled trial assessing pramlintide treatment in the setting of intensive insulin therapy in type 1 diabetes. Diabetes Care 2006; 29: 2189-95. (Among 296 patients with type 1 diabetes on mealtime insulin treated with pramlintide or placebo for 29 weeks, HbA1c levels decreased to a similar extent; side effects of pramlintide included nausea [63% vs 36%], anorexia [2% vs 9%] and vomiting [6% vs 13.5%]; no mention of ALT elevations or hepatotoxicity). 17003291
Aronne L, Fujioka K, Aroda V, Chen K, Halseth A, Kesty NC, Burns C, et al. Progressive reduction in body weight after treatment with the amylin analog pramlintide in obese subjects: a phase 2, randomized, placebo-controlled, dose-escalation study. J Clin Endocrinol Metab 2007; 92: 2977-83. (Among 204 obese subjects [not on insulin] treated with mealtime pramlintide vs placebo for 16 weeks, weight loss was greater with pramlintide [-3.6 kg] and side effects included nausea and hypoglycemia [8% vs 1%], and “no unexpected safety signals were observed as assessed by…clinical laboratory measures”). 17504894
Smith SR, Aronne LJ, Burns CM, Kesty NC, Halseth AE, Weyer C. Sustained weight loss following 12-month pramlintide treatment as an adjunct to lifestyle intervention in obesity. Diabetes Care 2008; 31: 1816-23. (Among 411 obese subjects given a life-style intervention with or without pramlintide (6 dose regimens) for 4 months, weight loss was greater with pramlintide [3.8 to 6.1 vs 2.8 kg] and the most common side effect was nausea [9% to 29% vs 2%]; no mention of ALT elevations or hepatotoxicity). 18753666
Riddle M, Pencek R, Charenkavanich S, Lutz K, Wilhelm K, Porter L. Randomized comparison of pramlintide or mealtime insulin added to basal insulin treatment for patients with type 2 diabetes. Diabetes Care 2009; 32: 1577-82. (Among 113 patients with type 2 diabetes treated with mealtime pramlintide or insulin for 24 weeks, there were similar decreases in HbA1c and fasting glucose, while adverse events included nausea [21% vs 0%] and hypoglycemia [55% vs 80%]). 19502544
Pencek R, Roddy T, Peters Y, De Young MB, Herrmann K, Meller L, Nguyen H, et al. Safety of pramlintide added to mealtime insulin in patients with type 1 or type 2 diabetes: a large observational study. Diabetes Obes Metab 2010; 12: 548-51. (Among 1297 patients with diabetes on insulin who started mealtime pramlintide therapy, severe hypoglycemia episodes occurred in 4.8% with type 1 and 2.8% with type 2 during the first 3 months, and declined to 1.8% and 0.3% during the second 3 months; no mention of ALT elevations or hepatotoxicity). 20518811
Younk LM, Mikeladze M, Davis SN. Pramlintide and the treatment of diabetes: a review of the data since its introduction. Expert Opin Pharmacother 2011; 12: 1439-51. (Review of the safety and efficacy of pramlintide in treatment of diabetes discusses adverse events of nausea, vomiting, anorexia and severe hypoglycemia; no mention of ALT elevations or hepatotoxicity). 21564002
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 was attributed to drugs for diabetes including pramlintide). 23419359
Drugs for type 2 diabetes. Treat Guidel Med Lett 2014; 12 (139): 17-24. (Concise overview and recommendations on the use of medications in diabetes mentions that pramlintide, an amylinomimetic agent that is injected subcutaneously before meals, reduces postprandial glucose excursions and promotes weight loss, but reduces HbA1c by only 0.5%; no mention of adverse events). 24566424
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: the DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury in the US collected between 2004 and 2012, 4 cases were attributed to drugs used for diabetes [metformin, glyburide, sitagliptin], but no cases were attributed to pramlintide). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Pramlintide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Pramlintide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Pramlintide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Pramlintide)